# Selpercatinib

## OVERVIEW

### Introduction

Selpercatinib is an oral selective inhibitor of the tyrosine kinase receptor encoded by RET (rearranged during transfection), a proto-oncogene which is mutated or altered in many cancers such a medullary thyroid cancer and non-small cell lung cancer. Serum aminotransferase elevations are common during therapy with selpercatinib and can lead to dose modifications or drug discontinuation, but clinically apparent liver injury with jaundice has not been described with its use.

### Background

Selpercatinib (sel per’ca ti nib) is an orally available, small molecule inhibitor of the tyrosine kinase receptor encoded by the proto-oncogene RET (rearranged during transfection), which is mutated or altered in several cancers including non-small cell lung cancer (NSCLC) and medullary thyroid cancer. The RET encoded tyrosine kinase receptor leads to stimulation of cell growth and proliferation which when overexpressed can become a cancer promoter by stimulating tumor cell proliferation, invasion and migration. Alterations in the RET gene, either mutations or RET fusions, are found in several forms of cancer, including 70% of medullary thyroid cancers and a small proportion of other forms of thyroid cancer and NSCLC. Therapy with selpercatinib has been shown to result in objective responses (either complete or partial) in a high proportion of patients with NSCLC and thyroid cancers with RET alterations. Selpercatinib was granted accelerated approved in the United States in 2020 for adults and children (aged 12 years or older) with advanced, unresectable or metastatic NSCLC, medullary thyroid cancer and thyroid cancers harboring RET mutations or RET gene fusions. Indications were subsequently extended to include adults with refractory, advanced solid tumors harboring a RET fusion. Selpercatinib is available in capsules of 40 and 80 mg under the brand name Retevmo. The recommended dose is 160 mg twice daily in adults and children weighing 50 kg or greater, and 120 mg twice daily in those weighing less than 50 kg. Side effects are common and arise in almost all patients treated with selpercatinib and can include dry mouth, diarrhea, systemic arterial hypertension, fatigue, constipation, nausea, poor appetite, myalgia, arthralgia, edema, anemia, elevations in serum creatinine, uric acid, and aminotransferase levels. Uncommon but potentially severe adverse events include interstitial lung disease, severe hypertension, prolongation of the QTc interval, hemorrhagic events, tumor lysis syndrome, impaired wound healing, hypersensitivity reactions, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of selpercatinib in patients with thyroid and non-small cell lung cancer, liver test abnormalities were frequent although usually mild. Some degree of ALT elevation arose in up to 55% of selpercatinib treated patients and were above 5 times the upper limit of normal (ULN) in 10% to 12%, arising mostly within the first few months of therapy; the median onset was at 6 weeks but with a range of 1 day to more than 2 years. In the preregistration trials that enrolled 531 patients, serum aminotransferase elevations led to dose interruptions and modifications in 5% to 6% but complete discontinuation in less than 1% of patients. ALT levels were closely monitored and did not lead to clinically apparent liver injury with jaundice or deaths from liver disease. Thus, selpercatinib therapy is associated with a high rate of transient serum enzyme elevations but has not been definitely linked to instances of clinically apparent liver injury with jaundice. The product label for selpercatinib recommends monitoring for routine liver tests before, at 2 week intervals during the first 3 months of therapy, and monthly thereafter as clinically indicated.

Likelihood score: E* (unproven but suspect cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum aminotransferase elevations during selpercatinib therapy is unknown, but the pattern of abnormalities and response to dose adjustments suggests some degree of low level, direct hepatotoxicity. Selpercatinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4, and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation of selpercatinib therapy until serum enzymes return to normal or near normal values. In patients with clinically apparent liver injury and jaundice, restarting therapy should be done with caution. Cross sensitivity to liver injury is uncommon among the tyrosine kinase inhibitors, but there is no information on shared adverse event sensitivity of selpercatinib with other RET inhibitors such as pralsetinib or other antineoplastic protein kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Related Drugs: Pralsetinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Selpercatinib – Retevmo®

DRUG CLASS

Antineoplastic Agents, Kinase Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Selpercatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Selpercatinib | 2152628-33-4 | C29-H31-N7-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 12 August 2023

Abbreviations: NSCLC, non-small cell lung cancer; RET, rearranged in transfection.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss selpercatinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213246Orig1s000MultidisciplineR.pdf (FDA website with product labels and initial clinical review of the safety and efficacy of selpercatinib; states that virtually all patients treated with selpercatinib [n=531] had at least one adverse event, including ALT elevations in 33% which were above 5 times ULN in 9%, led to dose interruption and dose reduction in 5-6% but to permanent discontinuation in only 0.4%; no patient developed clinically apparent liver injury with jaundice).
Drilon A, Oxnard GR, Tan DSW, Loong HHF, Johnson M, Gainor J, McCoach CE, et al. Efficacy of selpercatinib in RET fusion-positive non-small-cell lung cancer. N Engl J Med. 2020;383:813-824. (Among 144 adults with NSCLC and a RET-fusion mutation treated with selpercatinib for a median of 12 months, the objective response rate was 69% while adverse events were frequent, most commonly diarrhea, dry mouth, hypertension, fatigue and ALT elevations arising in 26% and to greater than 5 times ULN in 12%, but there were no hepatic related deaths). 32846060
Wirth LJ, Sherman E, Robinson B, Solomon B, Kang H, Lorch J, Worden F, et al. Efficacy of selpercatinib in RET-altered thyroid cancers. N Engl J Med. 2020;383:825-835. (Among 162 adults with RET altered thyroid cancers treated with selpercatinib, the objective response rate was 69-79% and all patients had at least one adverse event, most commonly dry mouth [46%], hypertension [43%], diarrhea [38%], fatigue [38%], poor appetite and nausea [35%] and ALT elevations [31%], which were above 5 times ULN in 11%, leading to dose modifications in 9% and discontinuation in 2 patients). 32846061
Illini O, Hochmair MJ, Fabikan H, Weinlinger C, Tufman A, Swalduz A, Lamberg K, et al. Selpercatinib in RET fusion-positive non-small-cell lung cancer (SIREN): a retrospective analysis of patients treated through an access program. Ther Adv Med Oncol. 2021;13:17588359211019675. (Among 50 patients with advanced or metastatic RET fusion-positive NSCLC treated in an open access program in 12 countries, the objective response rate was 68% and common “grade 3 or 4” adverse events included ALT or AST elevations in 10%, QTc prolongation in 4%, abdominal pain in 4%, and fatigue in 4%, but there were no treatment related deaths). 34178121
Drilon A, Subbiah V, Gautschi O, Tomasini P, de Braud F, Solomon BJ, Shao-Weng Tan D, et al. Selpercatinib in patients with RET fusion-positive non-small-cell lung cancer: updated safety and efficacy from the registrational LIBRETTO-001 phase I/II trial. J Clin Oncol. 2023;41:385-394. (Further follow up of 31 patients with advanced RET fusion-positive NSCLC treated with selpercatinib demonstrate an objective response rate of 84% in treatment-naïve and 61% in previously treated patients while adverse events arose in virtually all patients including edema [49%], diarrhea [47%], fatigue [43%], hypertension [41%] and ALT elevations in 36% which were above 5 times ULN in 11%). 36122315
Two drugs for RET-altered cancers (Retevmo and Gavreto). Med Lett Drugs Ther. 2023;65:e129-e131. (Concise review of the mechanism of action, clinical efficacy, safety and costs of selpercatinib and pralsetinib, two kinase inhibitors that act on RET gene altered cancers mentions that liver enzyme elevations are frequent and monitoring of ALT and AST levels is recommended).

## OTHER REFERENCE LINKS

Recent References on Selpercatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Selpercatinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Selpercatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Selpercatinib)